# Emicizumab

## OVERVIEW

### Introduction

Emicizumab is a humanized bispecific monoclonal antibody to two human coagulation factors – factor IXa and factor X – that mimics the activity of factor VIII and is used to prevent bleeding episodes in patients with severe hemophilia A (which is caused by factor VIII deficiency). Emicizumab has not been linked to serum enzyme elevations during therapy or to instances of idiosyncratic acute liver injury.

### Background

Emicizumab (e" mi ciz' ue mab) is a recombinant, humanized, bispecific monoclonal antibody to two human coagulation factors – factor IXa and factor X – that is used to prevent bleeding episodes in patients with severe hemophilia A. Hemophilia A is a serious genetic disease associated with deficiency in product of factor VIII leading to recurrent episodes of bleeding that result in major disability and premature death. Hemophilia A is typically treated with infusions of factor VIII isolated and concentrated from human plasma or produced by recombinant techniques. Some patients given factor VIII infusions, however, develop neutralizing antibodies which inhibit the anticoagulation activity of the infusions. Emicizumab is a recombinant bispecific monoclonal antibody that binds to both factor IXa and X, which mimics the co-factor function of factor VIII, bypassing its need in the coagulation cascade. In clinical trials, emicizumab was found to reduce bleeding episodes in patients with hemophilia A and antibodies to factor VIII. Emicizumab was approved for use for this indication in the United States in 2017. Emicizumab is available as a solution in single dose vials of 30, 60, 105 and 150 mg under the commercial name Hemlibra. The recommended dose is 3 mg/kg by subcutaneous injection once weekly for 4 weeks, followed by 1.5 mg/kg weekly. Side effects are not common, but can include headache, arthralgia and infection site reactions. Rare, but potentially severe adverse reactions may include hypersensitivity reactions and thromboembolic events.

### Hepatotoxicity

In clinical trials of emicizumab in patients with hemophilia A serum enzyme levels were rarely mentioned and laboratory test results were described as being stable or unremarkable. In preregistration studies of emicizumab there were no reports of clinically apparent liver injury with jaundice. There have been no reports of acute liver failure, chronic hepatitis or vanishing bile duct syndrome associated with emicizumab therapy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Liver Injury

The mechanism by which emicizumab might cause liver injury is unknown. Emicizumab is a monoclonal antibody and, like other proteins, is metabolized into amino acids and is unlikely to have intrinsic toxicity.

Drug Class: Hematologic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Emicizumab – Hemlibra®

DRUG CLASS

Hematologic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Emicizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Emicizumab | 1610943-06-0 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 20 October 2018

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; mentions rituximab and problems of reactivation of hepatitis B, but also states that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; eculizumab is not specifically mentioned).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy: ”No clinically significant changes in laboratory parameters were observed during treatment with emicizumab” and there were no instances of clinically apparent liver injury with jaundice).
Shima M, Hanabusa H, Taki M, Matsushita T, Sato T, Fukutake K, Fukazawa N, et al. Factor VIII-mimetic function of humanized bispecific antibody in hemophilia A. N Engl J Med 2016; 374: 2044-53. 27223146 (Among 18 Japanese patients with severe hemophilia A treated with 0.3, 1.0 or 3.0 mg/kg weekly for 12 weeks, bleeding rates decreased by 90% in all groups and 71-73% of patients had no bleeding episodes and there were no treatment related serious adverse events; no mention of ALT elevations or hepatotoxicity).
Shima M, Hanabusa H, Taki M, Matsushita T, Sato T, Fukutake K, Kasai R, et al. Long-term safety and efficacy of emicizumab in a phase 1/2 study in patients with hemophilia A with or without inhibitors. Blood Adv 2017; 1: 1891-9. 29296836 (Among 14 Japanese patients with severe hemophilia A who participated in a phase 1 trial [Shima 2016] and were continued on emicizumab for up to 33 months, bleeding rates remained low and therapy was “well tolerated” with no treatment related serious adverse events or thromboembolic events; no mention of ALT elevations or hepatotoxicity).
Oldenburg J, Mahlangu JN, Kim B, Schmitt C, Callaghan MU, Young G, Santagostino E, et al. Emicizumab prophylaxis in hemophilia A with inhibitors. N Engl J Med 2017; 377: 809-18. 28691557 (Among 109 patients with hemophilia A and factor VIII inhibitors who were treated with weekly injections of emicizumab or placebo, bleeding events were 87% less in emicizumab treated subjects while side effects were similar except for injection site reactions [15% vs 8%] and thrombotic microangiopathy [2% vs none]; no mention of ALT elevations or hepatotoxicity).
Mahlangu J, Oldenburg J, Paz-Priel I, Negrier C, Niggli M, Mancuso ME, Schmitt C, et al. Emicizumab prophylaxis in patients who have hemophilia A without inhibitors. N Engl J Med 2018; 379: 811-22. 30157389 (Among 152 patients with hemophilia A without factor VIII inhibitors who were treated with weekly or biweekly injections of emicizumab or no treatment, bleeding events were 958% less with emicizumab prophylaxis while side effects were similar except for injection site reactions, and there were on instances of thrombotic microangiopathy and no ALT elevations or hepatotoxicity).
Franchini M, Mannucci PM. Non-factor replacement therapy for haemophilia: a current update. Blood Transfus 2018; 16: 1-5. 29517971 (Review of efficacy and safety of non-factor VIII replacement therapy for hemophilia including use of emicizumab in patients with and without inhibitors; no mention of ALT elevations or hepatotoxicity).
Scott LJ, Kim ES. Emicizumab-kxwh: first global approval. Drugs 2018; 78: 269-74. 29357074 (Review of the development, mechanism of action, pharmacology, clinical efficacy and safety of emicizumab shortly after its approval for use in hemophilia A in the US; discusses adverse events of thromboembolism but does not mention ALT elevations or hepatotoxicity).

## OTHER REFERENCE LINKS

1 Recent References on Emicizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(theophylline/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Emicizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=theophylline)